# Pimavanserin

## OVERVIEW

### Introduction

Pimavanserin is an atypical antipsychotic used in the treatment of hallucinations and delusions in patients with Parkinson disease and psychosis. Use of pimavanserin is associated with a low rate of serum enzyme elevations during therapy but it has not been linked to instances of clinically apparent acute liver injury.

### Background

Pimavanserin (pim" a van' ser in) is non-dopaminergic atypical antipsychotic agent that appears to act as a selective inverse agonist of the serotonin (5-HT) 2A receptor. It has little or no activity against the 5-HT2B and 2C receptors which may account for its relative lack of adverse effects. The absence of dopamine receptor activity suggested that pimavanserin would be appropriate for patients with Parkinson disease psychosis which is usually resistant to the atypical antipsychotic medications and can be worsened by inhibition of dopaminergic transmission. Clinical studies demonstrated its effectiveness in Parkinson disease psychosis, and it was approved for this indication in the United States in 2016. Pimavanserin is available in capsules of 34 mg and tablets of 10 mg under the brand name Nuplazid. The typical dose is 34 mg once daily. Common side effects include somnolence, headache, confusion, hallucinations, and peripheral edema. Rare, but potentially serious adverse events include prolongation of the QT interval and increased risk of death in elderly patients with dementia related psychosis.

### Hepatotoxicity

Liver test abnormalities are uncommon (<1%) in patients taking pimavanserin, and the frequency of elevations appears to be similar to the rate that occurs with placebo therapy. No liver related serious adverse events or cases of clinically apparent liver injury were reported in the preregistration trials of pimavanserin. Pimavanserin has had limited clinical use since its approval and general availability, and it has not been implicated in published reports of clinically apparent liver injury. Thus, liver injury due to pimavanserin must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The potential mechanism by which pimavanserin might cause liver injury is not apparent. Pimavanserin is metabolized in the liver, primarily via CYP 3A and is susceptible to drug-drug interactions with agents that are potent inducers or inhibitors of CYP 3A activity.

### Outcome and Management

Liver test abnormalities during pimavanserin therapy are uncommon and typically transient, mild and not associated with symptoms or jaundice. There have been no reports of hepatitis, acute liver failure, chronic hepatitis or vanishing bile duct syndrome attributed to pimavanserin. It is unlikely that there is cross sensitivity to liver injury between pimavanserin and other atypical antipsychotic medications.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pimavanserin – Nuplazid®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pimavanserin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pimavanserin | 706779-91-1 | C25-H34-F-N3-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 05 June 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Meltzer HY, Elkis H, Vanover K, Weiner DM, van Kammen DP, Peters P, Hacksell U. (2012). Pimavanserin, a selective serotonin (5-HT)2A-inverse agonist, enhances the efficacy and safety of risperidone, 2mg/day, but does not enhance efficacy of haloperidol, 2mg/day: comparison with reference dose risperidone, 6mg/day. Schizophr Res. (Among 423 patients with an acute exacerbation of schizophrenia treated with one of five regimens combining pimavanserin or placebo with either haloperidol or risperidone for 6 weeks, combining low doses of risperidone with pimavanserin yielded better efficacy with lower rates of adverse events [including lower rates of ALT and AST elevations] compared to full doses of risperidone or haloperidol with or without pimavanserin).
Meltzer HY, Roth BL. (2013). Lorcaserin and pimavanserin: emerging selectivity of serotonin receptor subtype-targeted drugs. J Clin Invest. (Review of serotonin [5-HT] receptor activity and the advantages of highly selective receptor-subtype directed therapies, examples being lorcaserin, the 5-HT2C agonist [without 5-HT2B agonist activity] used for weight loss, and pimavanserin, the 5-HT2A inverse agonist [without dopaminergic activity] used for Parkinson disease psychosis).
Cummings J, Isaacson S, Mills R, Williams H, Chi-Burris K, Corbett A, Dhall R, et al. (2014). Pimavanserin for patients with Parkinson's disease psychosis: a randomised, placebo-controlled phase 3 trial. Lancet. (Among 199 patients with Parkinson disease psychosis treated with pimavanserin [40 mg daily] or placebo for 6 weeks, symptoms improved more with pimavanserin, and adverse event rates were similar; “laboratory assessments were unremarkable, and no safety signals were reported”).
Fox SH. (2014). Pimavanserin as treatment for Parkinson's disease psychosis. Lancet. (Editorial in response to Cummings [2014]).
Markham A. (2016). Pimavanserin: first global approval. Drugs. (Review of the development of pimavanserin, its mechanism of action, pharmacodynamics, inverse agonism of 5HT-2A, clinical efficacy, and safety; no mention of ALT elevations or hepatotoxicity).
(2016). Pimavanserin (Nuplazid) for Parkinson's disease psychosis. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of pimavanserin shortly after its approval in Parkinson psychosis in the US; no mention of ALT elevations or hepatotoxicity).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone, and lurasidone).
Mathis MV, Muoio BM, Andreason P, Avila AM, Farchione T, Atrakchi A, Temple RJ. (2017). The US Food and Drug Administration's perspective on the new antipsychotic pimavanserin. J Clin Psychiatry. (Summary of FDA’s review of the efficacy and safety of pimavanserin in Parkinson disease psychosis mentions that symptom improvements occurred in 80.5% of pimavanserin- vs 58% of placebo-treated patients, but concerns remain about the safety of antipsychotic agents in frail, elderly subjects with dementia).
Ballard C, Banister C, Khan Z, Cummings J, Demos G, Coate B, Youakim JM, Owen R, Stankovic S, Investigators ADP. (2018). Evaluation of the safety, tolerability, and efficacy of pimavanserin versus placebo in patients with Alzheimer's disease psychosis: a phase 2, randomised, placebo-controlled, double-blind study. Lancet Neurol. (Among 181 elderly patients with Alzheimer disease related psychosis treated with pimavanserin [34 mg] or placebo daily for 12 weeks, improvements in psychosis symptoms were more frequent with pimavanserin than placebo at 6 weeks but not at 12 weeks, while adverse event rates were similar; no patient on pimavanserin had ALT or AST elevations).
Fava M, Dirks B, Freeman MP, Papakostas GI, Shelton RC, Thase ME, Trivedi MH, et al. A phase 2, randomized, double-blind, placebo-controlled study of adjunctive pimavanserin in patients with major depressive disorder and an inadequate response to therapy (CLARITY). J Clin Psychiatry. 2019;80: 19m12928. (Among 207 patients with major depressive disorder and an inadequate response to antidepressant therapy who were treated with the addition of pimavanserin or placebo for 5 weeks, symptoms of depression improved more in those treated with pimavanserin but adverse events were more frequent [48% vs 27%], but there were no “clinically relevant” changes in the clinical laboratory test results).
Ballard CG, Kreitzman DL, Isaacson S, Liu IY, Norton JC, Demos G, Fernandez HH, et al. (2020). 015 Study Group. Long-term evaluation of open-label pimavanserin safety and tolerability in Parkinson's disease psychosis. Parkinsonism Relat Disord. (Among 459 patients with Parkinson disease psychosis treated in an open label extension study with pimavanserin for a median of 454 days, improvements in symptoms of psychosis were sustained and there were no hepatic severe adverse events and “no noteworthy changes from baseline” of ALT, AST or bilirubin).
Drugs for Parkinson's disease. (2021). Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs approved for therapy of Parkinson disease in the United States mentions that pimavanserin is FDA-approved for the treatment of Parkinson disease psychosis; no mention of ALT elevations or hepatotoxicity).
Tariot PN, Cummings JL, Soto-Martin ME, Ballard C, Erten-Lyons D, Sultzer DL, Devanand DP, et al. (2021). Trial of Pimavanserin in Dementia-Related Psychosis. N Engl J Med. (Among 217 patients with dementia-related psychosis who had a response to pimavanserin in a 12 week open label phase who were then continued on therapy or switched to placebo, relapse in psychotic symptoms was less frequent in those on pimavanserin than placebo [13% vs 28%], while adverse events rates were similar, headache, constipation and urinary tract infections being more frequent with treatment; no mention of ALT levels or hepatotoxicity).
Druschky K, Toto S, Bleich S, Baumgärtner J, Engel RR, Grohmann R, Maier HB, et al. (2021). Severe drug-induced liver injury in patients under treatment with antipsychotic drugs: data from the AMSP study. World J Biol Psychiatry. (Among 246 cases of severe liver injury due to antipsychotic medications identified in a prospective registry of German psychiatric hospitals between 1993 and 2016, 46 arose in 38,349 patients [0.12%] who received clozapine [34 as a single antipsychotic agent]; other commonly implicated agents being olanzapine [n=90 of 54,822: 0.16%], quetiapine [34 of 66,209: 0.05%] and risperidone [27 of 51,683: 0.05%]; two fatal cases occurred in olanzapine-treated patients; low rates were found for ziprasidone [no cases among 3568 patients treated] and aripiprazole [6 cases of 15,988 patients treated: 0.01%], pimavanserin not listed).
(2022). Drugs for cognitive loss and dementia. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of drugs available for therapy of cognitive loss and dementia in the US mentions that “Pimavanserin does not cause somnolence, gait changes, or extrapyramidal effects but does prolong the QT interval should not be used in patients with hepatic or severe renal impairment”).
Bugarski-Kirola D, Arango C, Fava M, Nasrallah H, Liu IY, Abbs B, Stankovic S. (2022). Pimavanserin for negative symptoms of schizophrenia: results from the ADVANCE phase 2 randomised, placebo-controlled trial in North America and Europe. Lancet Psychiatry. (Among 403 patients with schizophrenia with negative symptoms treated with pimavanserin or placebo added to ongoing antipsychotic medications, symptoms improved more with pimavanserin, and adverse events were similar in the two groups, most commonly headache and somnolence; no mention of ALT elevations or hepatotoxicity).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine, but none for risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine; pimavanserin is not discussed).
Gunther M, Dopheide JA. (2023). Antipsychotic safety in liver disease: a narrative review and practical guide for the clinician. J Acad Consult Liaison Psychiatry. (Review of the literature on hepatotoxicity of antipsychotic medications and guidance on their use in patients with liver disease characterizes chlorpromazine, clozapine, and olanzapine as having the greatest risk for causing liver injury, quetiapine and risperidone as having moderate risk, haloperidol as having low risk and paliperidone, aripiprazole, lurasidone, and loxapine as having low risk; pimavanserin is not discussed).
Layton JB, Forns J, McQuay LJ, Danysh HE, Dempsey C, Anthony MS, Turner ME. (2023). Mortality in patients with Parkinson’s disease-related psychosis treated with pimavanserin compared with other atypical antipsychotics: a cohort study. Drug Saf. (In a retrospective matched cohort of patients with Parkinson disease psychosis treated with pimavanserin compared to a group taking other atypical antipsychotics, overall mortality was slightly less in those on pimavanserin; no discussion of cause of death or liver disease).

## OTHER REFERENCE LINKS

1 Recent References on Pimavanserin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pimavanserin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pimavanserin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pimavanserin)